# Albiglutide

## OVERVIEW

### Introduction

Albiglutide is a recombinant DNA produced polypeptide analogue of human glucagon-like peptide-1 (GLP-1) which is used in combination with diet and exercise in the therapy of type 2 diabetes, either alone or in combination with other antidiabetic agents. There have been no published reports of hepatotoxicity attributed to albiglutide therapy.

### Background

Albiglutide (al" bi gloo' tide) is a glucagon-like peptide-1 (GLP-1) analogue (also called a GLP-1 receptor agonist) that acts like the native gastrointestinal hormone (incretin) to increase insulin secretion. Albiglutide reproduces the activity of GLP-1, binding to specific receptors on pancreatic beta cells and increasing insulin secretion, which can lead to improvement of glycemic control in patients with type 2 diabetes. Albiglutide is a recombinant DNA-produced polypeptide consisting of two 30-amino acid sequence molecules that are fused as a tandem repeat. The amino acid sequence of albiglutide is >90% homologous to endogenous human GLP-1(7-37) and differs only by a single amino acid substitution, which makes it resistant to degradation by dipeptidyl peptidase 4 (DPP4). The half-life of albiglutide is further prolonged by coupling of two recombinant molecules to human serum albumin. Albiglutide, like other GLP-1 analogues, must be given parenterally, but it has a half-life of 5 days which allows for once weekly dosing. Albiglutide was approved for use in the United States in 2014, and current indications are for management of glycemic control in adults with type 2 diabetes in combination with diet and exercise, with or without other oral hypoglycemic agents. Albiglutide is available under the brand name Tanzeum in a powder for reconstitution and is given by subcutaneous injection in an initial dose of 30 mg once weekly, which can be increased to 50 mg once weekly. Albiglutide is generally well tolerated, but side effects can be dose limiting and include injection site reactions, diarrhea, nausea, vomiting, dizziness, headache, fatigue and hypoglycemia. Rare adverse events include pancreatitis and hypersensitivity reactions.

### Hepatotoxicity

In large clinical trials, serum enzyme elevations were no more common with albiglutide therapy than with placebo or comparator agents, and no instances of clinically apparent liver injury were reported. Since licensure, there have been no published case reports of hepatotoxicity due to albiglutide and the product label does not list liver injury as an adverse event. Thus, liver injury due to albiglutide must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Albiglutide is a polypeptide and is metabolized to amino acids by serum and tissue proteases, and is unlikely to have any direct hepatotoxic potential. Albiglutide acts through the incretin pathway to affect glucose metabolism and, thus, is often grouped with other incretin-based antidiabetic mediations such as the DPP-4 inhibitors, sitagliptin, saxagliptin and linagliptin, and other GLP-1 analogues such as exenatide, which are also discussed in LiverTox.

References regarding the hepatotoxicity and safety of albiglutide are given with the Overview section of the GLP-1 Analogues.

Drug Class: Antidiabetic Agents

Other Drugs in the Subclass, Incretin-Based Drugs, Glucagon-Like Peptide-1 (GLP-1) Analogues: Dulaglutide, Exenatide, Liraglutide, Lixisenatide, Semaglutide

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Albiglutide – Tanzeum®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Albiglutide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Albiglutide | 782500-75-8 | Protein | Complex Polypeptide

## OTHER REFERENCE LINKS

1. Recent References on Albiglutide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Albiglutide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Albiglutide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Albiglutide)